# Dimenhydrinate

## OVERVIEW

### Introduction

Dimenhydrinate is a first generation antihistamine that is used for treatment or prevention of motion sickness or symptoms of nausea and dizziness. Dimenhydrinate has not been linked to instances of clinically apparent acute liver injury.

### Background

Dimenhydrinate (dye" men hye' dri nate) is the 8-chlorotheophylline salt of diphenhydramine and, thus, combines a first generation antihistamine with a xanthine that is added to counteract the drowsiness caused by diphenhydramine. This combination was approved as an over-the-counter agent in 2004 and is used largely for prevention of motion sickness and nausea. Dimenhydrinate is available in multiple generic forms as tablets 25 or 50 mg or oral solutions, most of which are available without prescription, a common brand name being Dramamine. A liquid formulation for intramuscular use is also available. The typical adult oral dose is 50 mg taken an hour before expected travel and up to three or four times daily. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Despite widespread use, dimenhydrinate has not been linked to liver test abnormalities or to clinically apparent liver injury. The reason for its safety may relate to its limited duration of use.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dimenhydrinate – Generic, Dramamine®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dimenhydrinate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dimenhydrinate | 523-87-5 | C17-H21-N-O.C7-H7-Cl-N4-O2 | Dimenhydrinate Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Dimenhydrinate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Dimenhydrinate/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dimenhydrinate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dimenhydrinate)